# Aducanumab

## OVERVIEW

### Introduction

Aducanumab is a human monoclonal antibody to amyloid β which has been approved for use in Alzheimer disease. Aducanumab is associated with a minimal rate of serum aminotransferase elevations during therapy and has not been linked to instances of clinically apparent liver injury.

### Background

Aducanumab (a” due can’ ue mab) is a human monoclonal IgG1 antibody directed against amyloid β which was developed as therapy for Alzheimer disease, based upon the theory that the dementia and neurological decline in Alzheimer disease is caused by accumulation of amyloid β oligomers and fibrils in the frontal lobes of the brain. Studies in animal models and in humans demonstrated that the monoclonal antibody causes a decrease in amyloid β accumulation as shown by advanced imaging techniques. Whether this results in improvement in dementia or lessens clinical progression of disease has not been shown. Aducanumab was evaluated in two large, randomized double-blind controlled trials in more than 3200 patients with early stages of Alzheimer disease and evidence of amyloid β plaques accumulation. Clinical responses were minimal although analysis of a subgroup of patients who received the highest dose in one of the two trials showed evidence of a significant improvement in the clinical dementia rating scale. Because of the severity of Alzheimer disease, the lack of any therapy that slows the progression of disease and the firm biologic basis for possible efficacy of aducanumab, it was given provisional approval in the United States in 2021 as therapy in patients with Alzheimer disease who have evidence of progression and presence of amyloid β plaques. The provisional approval requires conduct of a phase IV study to further evaluate and confirm its safety and efficacy. Aducanumab is available in single dose vials of 170 in 1.7 mL and 300 mg in 3 mL (100 mg/mL) under the brand name Aduhelm. The recommended dose is 10 mg per kilogram body weight administered intravenously (over approximately 1 hour) every 4 weeks with regularly scheduled evaluations for efficacy. Common side effects include infusion reactions, headache, falls, and amyloid related imaging abnormalities such as edema, hemorrhage and hemosiderin deposition. Uncommon, potentially severe adverse reactions include hypersensitivity reactions.

### Hepatotoxicity

Serum aminotransferase elevations were infrequent in the large controlled trials of aducanumab in Alzheimer disease. The elevations were generally mild-to-moderate in severity, transient and asymptomatic. In the preregistration trials there were no instances of clinically apparent liver injury or severe hepatic adverse events attributed to aducanumab. Clinical use outside of randomized controlled trials has been limited so far.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms by which aducanumab might cause liver injury are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of amyloid β accumulation or increase in its clearance would trigger liver injury or autoimmune liver conditions.

Drug Class: Monoclonal Antibodies, Alzheimer Disease Agents

Other Alzheimer Monoclonal Antibodies: Lecanemab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aducanumab – Aduhelm®

DRUG CLASS

Alzheimer Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aducanumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Aducanumab | 1384260-65-4 (https://pubchem.ncbi.nlm.nih.gov/substance/381127201) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 June 2021

Roberson ED. Alzheimer Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/Aducanumab_BLA761178_Dunn_2021_06_07.pdf (Multidisciplinary FDA review of aducanumab in support of its approval for use in Alzheimer disease in the US with discussion of safety, mentions that the laboratory findings from the prelicensure studies “did not identify any clinically meaningful change in patients treated with aducanumab”).
Ratner M. (2015). Biogen's early Alzheimer's data raise hopes, some eyebrows. Nat Biotechnol. (News report on release of interim results of a phase 1 study of aducanumab in Alzheimer disease which described decreases in β-amyloid plaques in treated patients as assessed by PET scan, but with no data on clinical efficacy in reversing or slowing progression of dementia; the results were encouraging enough directly go to phase 3 trials of the monoclonal antibody).
Selkoe DJ, Hardy J. (2016). The amyloid hypothesis of Alzheimer's disease at 25 years. EMBO Mol Med. (Analysis of the role of amyloid-β in the etiology of Alzheimer disease supported by findings that the dominant mutations in amyloid precursor protein [APP] or the protease that metabolizes presenilin and generates amyloid-β are associated with early onset dementia, suggesting that imbalance of generation and clearance of amyloid-β is the early and perhaps initiating factor in Alzheimer disease, and that monoclonal antibody therapy by increasing clearance might help correct the dyshomeostasis).
Ferrero J, Williams L, Stella H, Leitermann K, Mikulskis A, O'Gorman J, Sevigny J. (2016). First-in-human, double-blind, placebo-controlled, single-dose escalation study of aducanumab (BIIB037) in mild-to-moderate Alzheimer's disease. Alzheimers Dement (N Y). (Phase one study of escalating single doses of aducanumab [0.3, 1, 3 10, 20, 30 and 60 mg/kg] vs placebo in 53 patients with mild-to-moderate Alzheimer disease; four receiving the 60 mg/kg dose developed symptomatic amyloid related imaging abnormalities; no mention of ALT elevations or hepatotoxicity).
Sevigny J, Chiao P, Bussière T, Weinreb PH, Williams L, Maier M, Dunstan R, et al. (2016). The antibody aducanumab reduces Aβ plaques in Alzheimer's disease. Nature. (Among 165 patients with early Alzheimer disease treated with 1 of 4 doses of aducanumab [1, 3, 6, or 10 mg/kg] or placebo monthly for one year, those treated with the higher doses showed evidence of decrease in brain amyloid-β accumulation and a trend for clinical improvement, but also higher rates of vasogenic edema [37% to 40%] compared with placebo [5%]; ALT elevations arose in 4 of 125 [3.2%] on aducanumab vs none of 40 on placebo).
Hawkes N. (2017). Merck ends trial of potential Alzheimer's drug verubecestat. BMJ. (News report on the termination of a large randomized controlled trial of verubecestat [a small molecule inhibitor of β site amyloid precursor protein cleaving enzyme 1: BACE-1] because of futility).
Knopman DS, Jones DT, Greicius MD. (2021). Failure to demonstrate efficacy of aducanumab: An analysis of the EMERGE and ENGAGE trials as reported by Biogen, December 2019. Alzheimers Dement. (In a reanalysis of results from two large controlled trials of aducanumab in early Alzheimer disease, the authors conclude that there was likely a dose related effect on brain amyloid-β plaque accumulation, but the studies did not show evidence of clinical benefit, which calls for a third, adequately powered trial using higher doses and in more extended populations of subjects with Alzheimer disease).
Alexander GC, Emerson S, Kesselheim AS. (2021). Evaluation of aducanumab for Alzheimer disease: scientific evidence and regulatory review involving efficacy, safety, and futility. JAMA. (Summary of the conclusions of the FDA advisory committee on aducanumab which were based upon results of two phase III randomized controlled trials in early Alzheimer disease patients, both of which were terminated early after interim analyses indicated futility; but on post-hoc reanalysis, statistically significant benefit was found with the higher dose in one of the 2 trials; because of discrepancies in outcomes in the two trials and only slight clinical benefit achieved in one arm of the 2 studies, the committee recommended that aducanumab not be approved until another trial confirms the efficacy and safety of the high dose regimen).

## OTHER REFERENCE LINKS

1 Recent References on Aducanumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Aducanumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Aducanumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aducanumab)